# Trientine

## OVERVIEW

### Introduction

Trientine is an oral copper chelating agent used to treat Wilson disease. Trientine has not been associated with worsening of serum enzyme elevations during therapy or with cases of clinically apparent liver injury with jaundice.

### Background

Trientine (trye’ en teen) is an orally available copper chelating agent that is used to treat Wilson disease, an inherited abnormality of copper metabolism that leads to excess copper accumulation and injury to liver and brain. The metabolic defect in Wilson disease is caused by mutations in ATPase7B, a hepatic enzyme responsible for transmembrane transport and excretion of copper into the bile. The metabolic detect leads to accumulation of free copper in liver and blood and secondarily in other organs, particularly brain and kidney. The disease usually presents in childhood or adolescence with neurologic syndromes, signs of advanced liver disease and hemolytic anemia. Trientine is one of several copper chelating agents that lower blood and tissue copper levels and, when given chronically, prevent copper accumulation and injury in Wilson disease. Other copper chelating agents include d-penicillamine and dimercaprol (British anti-Lewisite [BAL]). Trientine has a polyamine-like structure and chelates copper by creating a stable complex with the four nitrogens in a plantar ring. Trientine complexed to copper is excreted in the urine. Trientine was approved for use in the United States in 1969, and current formal indications are for treatment of patients with Wilson disease who are intolerant of penicillamine. Trientine is available in capsules of 250 mg generically and under the brand name Syprine. The recommended dose is 750 to 1250 mg for adults and 500 to 750 mg for children given in 2 to 4 divided doses daily initially, which can be raised to a maximum of 2000 mg daily for adults and 1500 mg daily for children. Side effects are generally mild and may include headache, arthralgias, myalgias, nausea, anorexia, diarrhea, rash and renal dysfunction. Uncommon, but potentially severe adverse events include hypersensitivity reactions, lupus-like syndromes and pancytopenia.

### Hepatotoxicity

In clinical trials conducted in children with Wilson disease, serum aminotransferase levels generally improved or were stable during treatment with trientine. There have been no clinical reports of acute liver injury with jaundice attributed to trientine, even with overdoses. Patients with Wilson disease typically have mild-to-moderate serum aminotransferase elevations and may have signs and symptoms of cirrhosis. Improvement in liver injury in Wilson disease typically requires months to years of treatment.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Chelating Agents, Wilson Disease Agents

Other Drugs in the Subclass, Wilson Disease: Dimercaprol, Penicillamine, Zinc

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trientine – Generic, Syprine®

DRUG CLASS

Chelating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trientine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trientine | 112-24-3 | C6-H18-N4

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999; trientine is not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; chelating agents are not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1311-5. (Textbook of pharmacology and therapeutics).
Walshe JM. (1956). Penicillamine, a new oral therapy for Wilson's disease. Am J Med. (Initial studies on efficacy of oral penicillamine [ β,β-dimethyl cysteine, a monothiol] in inducing cupruresis in Wilson disease and lack of effect of cysteine and methionine; no toxic reactions were observed).
Walshe JM. (1970). Triethylene tetramine. Lancet. (Early studies of trientine used chemical preparations that had to be modified for human use and induced a prompt cupruresis, but were often contaminated with impurities that could be toxic).
Dubois RS, Rodgerson DO, Slovis TL, Hambidge KM, Bianchi TA. (1970). Triethylene tetramine dihydrochloride in Wilson’s disease. Lancet. (13 year old boy who developed leukopenia during penicillamine therapy responded to trientine [1 g daily] with prompt cupruresis, after which he was able to tolerate penicillamine).
Walshe JM. (1973). Copper chelation in patients with Wilson’s disease. A comparison of penicillamine and triethylene tetramine dihydrochloride. Q J Med. (Trientine induced a cupruresis in 18 patients with Wilson disease which was less than with penicillamine, but was substantial particularly in patients who had never been treated, suggesting that it might be an alternative for patients intolerant to penicillamine therapy).
Epstein O, Sherlock S. (1980). Triethylene tetramine dihydrochloride toxicity in primary biliary cirrhosis. Gastroenterology. (Four patients with primary biliary cirrhosis and elevated hepatic copper levels developed intolerable side effects within two weeks of starting trientine, marked by anorexia, fatigue, epigastric pain, muscle pains, skin rash and anemia).
Walshe JM. (1982). Treatment of Wilson’s disease with trientine(triethylene tetramine) dihydrochloride. Lancet. (Among 20 patients with Wilson disease who were intolerant of penicillamine therapy, all responded to trientine therapy although complications of penicillamine [lupus syndrome, elastosis perforans] did not always improve; no evidence of toxicity including hepatotoxicity).
Hill GM, Brewer GJ, Juni JE, Prasad AS, Dick RD. (1986). Treatment of Wilson's disease with zinc. II. Validation of oral 64copper with copper balance. Am J Med Sci. (Assessment of copper update using a radioactive copper uptake study demonstrated that patients with Wilson disease on zinc have a low [<1%], while those on no therapy or on penicillamine or trientine had normal update levels [~6%]).
Scheinberg IH, Jaffe ME, Sternlieb I. (1987). The use of trientine in preventing the effects of interrupting penicillamine therapy in Wilson's disease. N Engl J Med. (Eleven patients with Wilson disease who were unable to tolerate penicillamine therapy were treated successfully with trientine for 2-15 years; no mention of effect on copper levels or side effects).
Dubois RS, Rodgerson DO, Hambidge KM. (1990). Treatment of Wilson's disease with triethylene tetramine hydrochloride (Trientine). J Pediatr Gastroenterol Nutr. (Seven patients, ages 13 to 33 years, with Wilson disease intolerant of penicillamine were treated with trientine for up to 16 years with stable disease and "no serious untoward side effects").
Saito H, Watanabe K, Sahara M, Mochizuki R, Edo K, Ohyama Y. (1991). Triethylene-tetramine (trien) therapy for Wilson’s disease. Tohoku J Exp Med. (Among 4 Japanese patients with Wilson disease intolerant of penicillamine treated with trientine, all had increased cupruresis and clinical improvement without adverse effects).
Morita J, Yoshino M, Watari H, Yoshida I, Motohiro T, Yamashita F, Okano Y, Hashimoto T. (1992). Wilson's disease treatment by triethylene tetramine dihydrochloride (trientine, 2HCl): long-term observations. Dev Pharmacol Ther. (19 year old girl and 14 year old boy with Wilson disease and intolerant of penicillamine therapy were treated with trientine [2-3 g daily] for 8 years, with excellent cupruresis and clinical responses and no adverse events except for low serum iron levels without anemia).
Condamine L, Hermine O, Alvin P, et al. (1993). Acquired sideroblastic anaemia during treatment of Wilson’s disease with triethylene tetramine dihydrochloride. Br J Haematol. (15 year old girl with severe Wilson disease had marked clinical improvement, but developed sideroblastic anemia 4 months after switching from penicillamine to high doses of trientine [2250 mg daily], which resolved on lowering the dose).
Moreno Pérez-Crespo JL, García de la Rocha ML, Martín Araguz A, Olmedilla N, Rodríguez Arias CA, Porta J, Moreno Martínez JM. (1995). Rev Neurol. (20 year old woman with Wilson disease and cirrhosis with thrombocytopenia was treated with trientine rather than penicillamine and had a prompt cupruresis).
Dahlman T, Hartvig P, Löfholm M, Nordlinder H, Lööf L, Westermark K. (1995). Long-term treatment of Wilson's disease with triethylene tetramine dihydrochloride (trientine). QJM. (Among 19 Swedish patients with Wilson disease treated with trientine for 4 months to 17 years, 16 had clinical improvement whereas one deteriorated and was switched to penicillamine; serious long term outcomes included liver failure requiring transplantation in 2, and colitis responding to withdrawal of the drug in 2 patients).
Perry AR, Pagliuca A, Fitzsimons EJ, Mufti GJ, Williams R. (1996). Acquired sideroblastic anaemia induced by a copper-chelating agent. Int J Hematol. (19 year old girl with Wilson disease developed myasthenia gravis after 2 years of penicillamine therapy, was switched to trientine [2.4 g daily] and soon developed a sideroblastic anemia, which improved on reduction of the trientine dose [0.9 g daily]).
Harders H, Cohnen E. (1977). Preparation of and clinical experiences with trien for the treatment of Wilson’s disease in absolute intolerance of D-penicillamine. Proc R Soc Med. (28 year old woman who was intolerant to penicillamine was successfully treated with trientine prepared by an improved method, with prompt cupruresis and improvement in neurologic symptoms).
Ala A, Walker AP, Ashkan K, Dooley JS, Schilsky ML. (2007). Wilson's disease. Lancet. (Review of the clinical features, pathogenesis, genetics, diagnosis and treatment including role of trientine).
Roberts EA, Schilsky ML. (2008). AASLD. Diagnosis and treatment of Wilson disease: an update. Hepatology. (Thorough review of the cause, natural history, diagnosis and treatment of Wilson disease, with specific recommendations for use of penicillamine, trientine and zinc).
Walshe JM. (2009). The conquest of Wilson's disease. Brain. (History of the initial description of Wilson disease, its link to copper accumulation, and therapies several of which were developed by the author).
Lu J, Poppitt SD, Othman AA, Sunderland T, Ruggiero K, Willett MS, Diamond LE, et al. (2010). Pharmacokinetics, pharmacodynamics, and metabolism of triethylenetetramine in healthy human participants: an open-label trial. J Clin Pharmacol. (Studies in 24 healthy volunteers demonstrated that trientine increases urine copper excretion and its effects were not influenced by N-acetyltransferase [NTA] 2 phenotypes).
Weiss KH, Stremmel W. (2012). Evolving perspectives in Wilson disease diagnosis: treatment and monitoring. Curr Gastroenterol Rep. (Review of the diagnosis and management of Wilson disease, including the role of genetic testing and the choice of medical therapies).
Weiss KH, Thurik F, Gotthardt DN, Schäfer M, Teufel U, Wiegand F, Merle U, et al. (2013). EUROWILSON Consortium. Efficacy and safety of oral chelators in treatment of patients with Wilson disease. Clin Gastroenterol Hepatol. (Retrospective analysis of 380 patients with Wilson disease from referral centers in Germany and Austria, including 141 who were treated with trientine and 326 with penicillamine, found higher rate of improvement with penicillamine, but also higher rate of adverse events leading to discontinuation [29% vs 7%], although there were no therapy related deaths; reasons for discontinuation in the trientine group included arthralgias, gastrointestinal upset, myalgias, leukopenia, rash, lupus erythematosus and increase in ANA titers; no mention of ALT elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which was attributed to trientine or other agents used to treat Wilson disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to penicillamine but none were attributed to trientine or other drugs for Wilson disease).
Hashim A, Parnell N. (2015). A case of trientine overdose. Toxicol Int. (40 year old man with Wilson disease and cirrhosis took an overdose of trientine [60 mg] and developed dizziness, nausea and vomiting that resolved within 48 hrs; no mention of ALT elevations or hepatotoxicity).
Ala A, Aliu E, Schilsky ML. (2015). Prospective pilot study of a single daily dosage of trientine for the treatment of Wilson disease. Dig Dis Sci. (Among 8 patients with Wilson disease on long term copper chelation therapy who were switched to once-daily weight based trientine, all tolerated therapy well with stable copper balance and minor fluctuations in serum aminotransferase levels).
Pfeiffenberger J, Beinhardt S, Gotthardt DN, Haag N, Freissmuth C, Reuner U, Gauss A, et al. (2018). Pregnancy in Wilson's disease: management and outcome. Hepatology. (Among 282 pregnancies in 136 patients with Wilson disease analyzed in a retrospective, multicenter study, spontaneous abortion was less common among patients being treated with penicillamine [17%] or zinc [10%] than untreated patients [41%], which was proportionally greater than with trientine [28%] and similar to that in patients who discontinued therapy during pregnancy [36%]; worsening of liver disease arose in some patients on treatment but was self-limiting and resolved after delivery; birth defects were found in 7 of 209 [3%] newborns overall and in 4 of 98 women taking penicillamine).
Roberts EA. (2018). Update on the diagnosis and management of Wilson disease. Curr Gastroenterol Rep. (Review of recent advances in the understanding of the pathogenesis, clinical features, diagnosis, and treatment of Wilson disease).
Appenzeller-Herzog C, Mathes T, Heeres MLS, Weiss KH, Houwen RHJ, Ewald H. (2019). Comparative effectiveness of common therapies for Wilson disease: A systematic review and meta-analysis of controlled studies. Liver Int. (Systematic review of literature on therapies of Wilson disease found no differences in outcomes with penicillamine vs zinc, but higher rates of adverse events and discontinuations with penicillamine; no mention of hepatotoxicity or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Trientine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Trientine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Trientine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trientine)